# Clarithromycin

## OVERVIEW

### Introduction

Clarithromycin is a semisynthetic macrolide antibiotic used for a wide variety of mild-to-moderate bacterial infections. Clarithromycin has been linked to rare instances of acute liver injury that can be severe and even fatal.

### Background

Clarithromycin (kla rith" roe mye' sin) is a semisynthetic macrolide antibiotic used widely to treat mild-to-moderate bacterial infections caused by sensitive agents. Clarithromycin, like other macrolide antibiotics such such as eythromycin and azithromycin, is bacteriostatic against many gram positive bacteria including many strains of streptococci, staphylococci, clostridia, corynebacteria, listeria, haemophilus sp., moxicella, and Neisseria meningitidis. Clarithromycin is also active against Chlamydia pneumoniae, Helicobacter pylori, and several atypical mycobacteria. Macrolide antibiotics act by inhibiting protein synthesis of bacteria by binding to the 50S ribosomal element. Resistance occurs by several mechanisms. Clarithromycin was approved for use in the United States in 1993, and currently more than 3 million prescriptions are filled yearly. Typical indications are for upper respiratory infections, bronchitis, sinusitis, community acquired pneumonia, and skin and tissue infections. Clarithromycin is also used for infections caused by Chlamydia pneumoniae, Helicobacter pylori and atypical mycobacteria. Clarithromycin is available in tablets of 250 and 500 mg generically under several commercial names including Biaxin, Claripen and Clacid. Extended release formulations are also available. The typical course is 250 to 500 mg twice daily (or 1000 mg extended release tablets once daily) for 7 to 14 days. Clarithromycin is given chronically in some situations such as prophylaxis against mycobacterium avium complex in patients with HIV infection. Clarithromycin is generally well tolerated, but side effects can include nausea, abdominal pain, diarrhea, dyspepsia, headache, dizziness, angioedema and rash.

### Hepatotoxicity

Clarithromycin, like other macrolide antibiotics, has been linked to a low rate of acute, transient and usually asymptomatic elevations in serum aminotransferase levels which occur in 1% to 2% of patients treated for short periods and a somewhat higher proportion of patients given clarithromycin long term. Asymptomatic elevations in serum enzymes are particularly common among elderly patients given higher doses of clarithromycin.

Clarithromycin can also cause acute, clinically apparent liver injury with jaundice, which is estimated to occur in 3.8 per 100,000 prescriptions. The liver injury usually appears within the first 1 to 3 weeks after initiation of treatment and can arise after clarithromycin is stopped. The pattern of liver enzyme elevations varies, but the resulting hepatitis is often cholestatic and can be prolonged (Case 1). Allergic signs and symptoms have not been consistently reported. While cholestatic hepatitis is most typical of clarithromycin induced liver injury, rare cases with hepatocellular injury and abrupt onset have been described. These hepatocellular cases are more likely to be severe and can result in acute liver failure. However, in most instances, recovery occurs within 4 to 8 weeks of withdrawal of the medication. The typical latency, clinical pattern and course of the cholestatic hepatitis due to clarithromycin resembles that of the other macrolide antibiotics.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The cause of the idiosyncratic liver injury due to clarithromycin is unknown, but the rapidity of onset and prompt recurrence upon rechallenge suggests hypersensitivity. Clarithromycin is extensively metabolized by the microsomal cytochrome P450 system and is a potent inhibitor of CYP 3A4, for which reason it can cause serious drug-drug interactions with agents that are metabolized by CYP 3A4 such as siapride, terfenadine, ergotamine, colchicine, amlodipine, diltiazem and many statins and benzodiazepines. Thus, in some situations, clarithromycin may lead to liver injury from a concurrent medication because of a decrease in its metabolism and increased blood levels.

### Outcome and Management

The minor serum aminotransferase elevations that appear during therapy with clarithromycin are usually benign, asymptomatic and resolve rapidly whether or not clarithromycin is stopped. The acute hepatic injury with jaundice, however, can be prolonged and troublesome and lead to loss of intrahepatic bile ducts and vanishing bile duct syndrome. Rare instances of fatality from clarithromycin induced liver disease have been reported. It is unclear whether there is cross sensivity to hepatic injury about the different macrolide antibiotics, but after severe injury from one macrolide, it is prudent to avoid use of the others.

Drug Class: Antiinfective Agents, Macrolide Antibiotics

## CASE REPORT

### Case 1. Cholestatic hepatitis after clarithromycin.

[Modified from: Sousa C, Correia J, Santos J, Silvestre F, Bernardo A. [Cholestatic hepatitis probably induced by clarithromycin] Gastroenterol Clin Biol 1997; 21: 632-3. French. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9587506)]

A 74 year old man with acute bronchitis was treated with a 10 day course of clarithromycin (500 mg daily) and developed nausea and jaundice by day 7. Because of itching and worsening symptoms, he sought medical advice and was hospitalized. He was jaundiced and had right upper quadrant tenderness over the liver, but was not febrile. He denied a history of alcohol intake and had no risk factors for viral hepatitis. Laboratory tests showed marked elevations in alkaline phosphatase and bilirubin levels with moderate increases in ALT and AST levels. He tested negative for markers of hepatitis A, B and C, had low levels of antinuclear and anti-smooth muscle antibody, and liver ultrasound was normal. A liver biopsy showed intrahepatic cholestasis with centrolobular ballooning degeneration, portal inflammation with a prominence of eosinophils, and ductular proliferation. His other medications that he took chronically were stopped at the same time. He recovered over the next few weeks and all liver tests were normal in follow up 3 months later.

#### Key Points

Medication: | Clarithromycin (500 mg daily for 10 days)
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 1 week
Recovery: | Complete within three months
Other medications: | Digoxin, captopril, nitropaste, aminophylline, salbutamol, and budesonide (by inhalation) for several years

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Nausea and jaundice arose on day 7 of a 10 day course of clarithromycin
2 weeks | 5 days | 520 | 3090 | 25.1 | Admission
3 weeks | 11 days | 256 | 2477 | 30.4 | Liver Biopsy
4 weeks | 18 days | 155 | 1108 | 8.5
5 weeks | 27 days | 84 | 445 | 4.0
3 months | 3 months | 19 | 117 | 0.8
Normal Values | | <33 | <117 | <1.2

* Converted from µmol (1.0 mg/dL = 17.1 µmol).

#### Comment

A convincing history for drug induced liver disease and the only new medication taken was clarithromycin. The latency was short (one week) as is typical for macrolide induced hepatotoxicity, and the pattern of liver enzyme elevations was cholestatic which also is typical. Despite the patient’s age and depth of jaundice, recovery was complete, taking somewhat longer than usual for this form of drug induced liver injury probably because of the height of the bilirubin and alkaline phosphatase elevations.

## CASE REPORTS SUBMITTED TO LIVERTOX

Clinical cases of drug-induced liver injury that have been submitted to LiverTox ("Submit a Case Report" (https://livertox.niddk.nih.gov/)) are available for review. Most of these reference cases are from the Drug-Induced Liver Injury Network, but others are from users of LiverTox who have submitted data from an actual clinical case. All cases have been reviewed and cleared of personal identifiers and a brief comment added by the LiverTox editors. Click on the following link to view the submitted case reports that have been made publically available.

[underlined: Submitted Cases on Clarithromycin] (https://livertox.niddk.nih.gov/Home/ReferenceCases/clarithromycin)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clarithromycin — Generic, Biaxin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=clarithromycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clarithromycin | 81103-11-9 | C38-H69-N-O13 | Clarithromycin structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2017

Moseley RH. Macrolide antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 466-7. (Expert review of macrolide antibiotic induced liver injury mentions that clarithromycin has been implicated in cases of cholestatic hepatitis, particularly in elderly patients on high doses).
MacDougall C, Chambers HF. Macrolides and ketolides. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1529-34. (Textbook of pharmacology and therapeutic s).
Wallace RJ Jr, Brown BA, Griffith DE. Drug intolerance to high-dose clarithromycin among elderly patients. Diagn Microbiol Infect Dis 1993; 16: 215-21. (Elevations of Alk P and GGT occurred in 5 of 14 elderly patients receiving clarithromycin in high doses [2 g/day] after 1 to 6 weeks of therapy, resolving slowly; no jaundice and few symptoms). 8477575
Yew WW, Chau CH, Lee J, Leung CW. Cholestatic hepatitis in a patient who received clarithromycin therapy for a Mycobacterium chelonae lung infection. Clin Infect Dis 1994; 18: 1025-6. (62 year old man with atypical mycobacterial disease received high doses of clarithromycin [2 g/day] and developed rising Alk P [110 to 447 U/L], bilirubin [0.5 to 2.2 mg/dL] and ALT [18 to 46 U/L] during 2 months of therapy, resolving slowly once drug was stopped). 8086541
Brown BA, Wallace RJ Jr, Griffith DE, Girard W. Clarithromycin-induced hepatotoxicity. Clin Infect Dis 1995; 20: 1073-4. (Letter in response to Yew et al. pointing out similarity of details in case to those from their study [Wallace 1993] and adding two further cases of marked Alk P and GGT elevations during high dose clarithromycin therapy, particularly in elderly and frail patients, resolving slowly over 1 to >3 months; not seen with lower doses). 7795060
Cadranel JF, Bachmeyer C, Pras V, Bouraya D, Pourvillain S, Biour M, Mougeot-Martin M. [Acute symptomatic cytolytic hepatitis probably related to clarithromycin] Gastroenterol Clin Biol 1996; 20: 1034-5. French. (41 year old woman developed acute abdominal pain after 3 days of clarithromycin therapy [bilirubin 0.7 mg/dL, ALT 10 times ULN, Alk P normal], resolving with a month of stopping). 9119179
Shaheen N, Grimm IS. Fulminant hepatic failure associated with clarithromycin. Am J Gastroenterol 1996; 91: 394-5. (25 year old man developed jaundice and abdominal pain after 9 days of clarithromycin [bilirubin 12.6 rising to 32 mg/dL, ALT 4790 U/L, Alk P 225 U/L], with subsequent signs of liver failure leading to transplant 11 days after admission; patient died postoperatively). 8607519
Sousa C, Correia J, Santos J, Silvestre F, Bernardo A. [Cholestatic hepatitis probably induced by clarithromycin] Gastroenterol Clin Biol 1997; 21: 632-3. French. (74 year old man developed jaundice after 7th day of 10-day course of clarithromycin [bilirubin 25.1 mg/dL, ALT 498 U/L, Alk P 3148 U/L], resolving fully within 3 months of stopping: Case 1). 9587506
Vial T, Biour M, Descotes J, Trepo C. Antibiotic-associated hepatitis: update from 1990. Ann Pharmacother 1997; 31: 204-20. (Extensive review including discussion of 3 macrolides [erythromycin, clarithromycin and azithromycin], ALT elevations occurred in 0.4-1.2% of patients treated, but similar rates found in placebo controls; rare instances of cholestatic hepatitis have been reported with all three). 9034423
Baylor P, Williams K. Interstitial nephritis, thrombocytopenia, hepatitis, and elevated serum amylase levels in a patient receiving clarithromycin therapy. Clin Infect Dis 1999; 29: 1350-1. (77 year old man developed acute interstitial nephritis and thrombocytopenia with mild increases in AST and CPK without jaundice after 5 days of clarithromycin therapy, but also 5 days after a 7 day course of trimethoprim/ sulfamethoxazole; all abnormalities subsequently resolved). 10525003
Fox JC, Szyjkowski RS, Sanderson SO, Levine RA. Progressive cholestatic liver disease associated with clarithromycin treatment. J Clin Pharmacol 2002; 42: 676-80. (59 year old woman developed jaundice a few days after stopping a 3 day course of clarithromycin [bilirubin 17 mg/dL, ALT 428 U/L, Alk P 2831 U/L], eventually leading to liver and renal failure and death 3 weeks later). 12043957
Masiá M, Gutiérrez F, Jimeno A, Navarro A, Borrás J, Matarredona J, Martín-Hidalgo A. Fulminant hepatitis and fatal toxic epidermal necrolysis (Lyell disease) coincident with clarithromycin administration in an alcoholic patient receiving disulfiram therapy. Arch Intern Med 2002; 162: 474-6. (47 year old man developed severe rash 1 month after starting disulfiram and 1 week after starting clarithromycin [bilirubin 15.3 mg/dL, ALT 2603 U/L, Alk P 240 U/L], with subsequent liver failure and death; authors hypothesized that there were drug interactions with combined inhibition of CYP 3A4 and 2E1 by the 2 agents). 11863483
Christopher K, Hyatt PA, Horkan C, Yodice PC. Clarithromycin use preceding fulminant hepatic failure. Am J Gastroenterol 2002; 97: 489-90. (40 year old woman developed nausea, abdominal pain and fever at the end of a 7 day course of clarithromycin, with subsequent jaundice and hepatic failure [bilirubin 33.4 mg/dL, ALT 1974 U/L, Alk P 1095 U/L, protime 21 seconds], dying 13 days after presentation). 11866297
Tietz A, Heim MH, Eriksson U, Marsch S, Teracciano L, Krähenbühl S. Fulminant liver failure associated with clarithromycin. Ann Pharmacother 2003; 37: 57-60. (58 year old woman with heart disease developed jaundice after 4 days of clarithromycin treatment [bilirubin 4.6 mg/dL, ALT 13,853 U/L, Alk P 258 U/L, prothrombin index 10%], recovering within 2 weeks; possibly due to ischemic hepatitis). 12503933
Sopena N, Martínez-Vázquez C, Rodríguez-Suárez JR, Segura F, Valencia A, Sabrià M. Comparative study of the efficacy and tolerance of azithromycin versus clarithromycin in the treatment of community-acquired pneumonia in adults. J Chemother 2004; 16: 102-3. (Comparison of 3 day azithromycin vs 10-14 day clarithromycin course in 70 adult patients with pneumonia showing similar efficacy [>90%] and frequency of side effects [26.5% vs 25%], with no mention of hepatic injury). 15078008
Peters TS. Do preclinical testing strategies help predict human hepatotoxic potentials? Toxicol Pathol 2005; 33: 146-54. (FDA scientist review of discrepancies between preclinical testing and toxicity identified when agent becomes generally available; clarithromycin is used as an example). 15805066
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Among 4690 reports of drug induced liver injury with fatal outcome reported to WHO, clarithromycin was among the top 20 agents implicated [51 cases]). 16054882
Giannattasio A, D'Ambrosi M, Volpicelli M, Iorio R. Steroid therapy for a case of severe drug-induced cholestasis. Ann Pharmacother 2006; 40: 1196-9. (Adolescent girl developed jaundice 1 week after 15 day course of clarithromycin and nimesulide [ALT 69 U/L, GGT normal and bilirubin 10.6 mg/dL]; prolonged jaundice led to use of prednisone [starting at 1 mg/kg/day] with rapid improvement, stopped after 12 weeks, ultimately complete recovery). 16720710
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 5 cases were attributed to telithromycin and 3 to azithromycin as single agents, but none to erythromycin or clarithromycin). 18955056
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review; the macrolide antibiotics may cause cholestatic hepatitis at an estimated rate of 3.6 for erythromycin, 3.8 for clarithromycin, and 5.5 cases per 100,000 prescriptions for telithromycin, compared to 10 for sulfonamides and 2000 per 100,000 for isoniazid). 20107858
Caramaschi P, Mahamid H, Bambara LM, Biasi D. Liver impairment after concomitant administration of bosentan and clarithromycin in systemic sclerosis. Joint Bone Spine 2010; 77: 81-2. (Two cases, 47 and 69 year old women with systemic sclerosis were treated with bosentan without difficulty, but developed ALT elevations [peak 503 and 94 U/L, Alk P 263 and 293 U/L] without jaundice within 5-7 days of starting clarithromycin, which resolved with stopping both or either, attributed to drug-drug interactions). 20022782
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children includes 63 cases attributed to azithromycin, 60 to erythromycin and 35 to clarithromycin). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 31 were due to antibiotics, one of which was attributed to clarithromycin).20949552
Hydzik P, Gawlikowski T, Groszek B. [Drug-induced erythrodermia complicated by multiorgan failure--case report]. Przegl Lek 2011; 68: 503-5. Polish. (23 year old young woman developed toxic epidermal necrolysis with liver, lung and renal injury two weeks after starting a course of clarithromycin, ibuprofen and acetaminophen [bilirubin 10.7 mg/dL, ALT 915 U/L, GGT 252 U/L, INR 1.7], with ultimate complete resolution). 22010450
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 6 [1.1%] attributed to macrolide antibiotics). 22379337
Maggi P, Solarino B, Cassano P, Tattoli L, Leone A, Maselli E, Angarano G. Fatal fulminant hepatitis following administration of clarithromycin in a patient chronically treated with antipsycotic drugs. Immunopharmacol Immunotoxicol. 2013; 35: 191-4. (23 year old man developed nausea, diarrhea and fever within 3 days of starting a 5 day course of clarithromycin, with subsequent jaundice [bilirubin 9.6 mg/dL, ALT 4065 U/L] followed by hepatic failure, coagulopathy, intracerebral hemorrhage and death). 22804484
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Giaquinto C, Picelli G, Oteri A, et al. Idiopathic acute liver injury in paediatric outpatients: incidence and signal detection in two European countries. Drug Saf 2013; 36: 1007-16. (Analysis of 3 large, electronic healthcare databases identified 785 cases of acute liver injury of unknown cause, 110 of which occurred in relationship to a prescription, the highest relative risk [RR] being associated with clarithromycin [RR=25.9], amoxicillin/ clavulanate [RR=18.6] and amoxicillin [RR=6.0]). 23591830
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to clarithromycin or other macrolide antibiotics). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to clarithromycin [acute liver failure], but none were attributed to other macrolide antibiotics). 24552865
Ferrajolo C, Coloma PM, Verhamme KM, Schuemie MJ, de Bie S, Gini R, Herings R, et al.; EU-ADR consortium. Signal detection of potentially drug-induced acute liver injury in children using a multi-country healthcare database network. Drug Saf 2014; 37: 99-108. (Analyses of large spontaneous reporting databases from 3 European countries between 1995 and 2010 identified 125 drugs with at least one exposed case of unexplained acute liver injury in children, 20 of which had a statistically significant association, including clarithromycin [5 cases] and erythromycin [4 cases]). 24446276
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy 2014; 34: 336-49. (In a nested case control analysis of a health care network database of persons between 2001 and 2009, 8 selected antibiotics were assessed for association with risk of hospitalization for liver injury, adjusted relative risks being significantly elevated for levofloxacin [3.2], moxifloxacin [2.3], doxycycline [2.5], amoxicllin/clavulanate [2.5] and amoxicillin [2.3], but not for clarithromycin [1.8], telithromycin [1.7] or cefuroxime [0.9]). 24865821
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 29 [3.2%] due to marolides of which 18 were linked to azithromycin, 2 to clarithromycin, 2 erythromycin and 7 telithromycin). 25754159
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf 2017; 40: 305-15. (In a health care database of 429,772 children in Italy and the Netherlands followed between 2008 and 2010, 938 cases of liver injury of uncertain cause were identified, the rate being higher in those with current use of antibiotics [12% vs 3.6%] for an adjusted odds rate ratio [aOR] of 3.2; specific antibiotics most commonly implicated were fluoroquinolones [19.0], cephalosporins [4.5], macrolides [3.5] and penicillins [2.6], and specific aOR for clarithromycin of 5.6 [12 cases]). 28025733
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, including 2 cases attributed to azithromycin, but none to clarithromycin or other macrolides). 27981596

## OTHER REFERENCE LINKS

1. Recent References on Clarithromycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(clarithromycin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222006/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Clarithromycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=clarithromycin)